# Avelumab

## OVERVIEW

### Introduction

Avelumab is a human monoclonal antibody to programmed cell death ligand 1 (PD-L1), which acts as a checkpoint inhibitor and is used in the immunotherapy of several forms of advanced or metastatic cancer. Avelumab therapy has major side effects and particularly immune related conditions, including acute hepatocellular and cholestatic liver injury which can be serious and even life threatening.

### Background

Avelumab (av el' ue mab) is a human recombinant monoclonal IgG1 antibody to the programmed cell death ligand-1 (PD-L1), which has distinctive immunomodulatory activity and is used as a checkpoint inhibitor in cancer immunotherapy. The programmed cell death receptor 1 (PD-1) is an important checkpoint molecule that is expressed on activated T and B cells. Binding of the ligand to PD-1 activates programmed cell death pathways that terminate or down regulate cytotoxic T cell responses. Monoclonal antibody binding to the PD-L1 prevents its engagement with the PD receptor and subsequent induction of the cellular pathways that down regulate T cell responses. Inhibition of this pathway allows for a continued activation and proliferation of T cell responses. The subsequent enhancement of cytotoxic reactivity may play a beneficial role in cancer immunotherapy by breaking immunological tolerance to cancer cell neo-antigens. In several multicenter studies, avelumab therapy resulted in objective responses in patients with advanced, metastatic or unresectable malignant neoplasms, and a proportion of patients had a long term remission. Avelumab was approved for use in metastatic Merkel cell carcinoma and advanced, refractory urothelial bladder carcinoma in the United States in 2017, and was subsequently approved for use in combination with axitinib in advanced renal cell carcinoma. Avelumab is available in single use 10 mL vials of 200 mg (20 mg/mL) under the brand name Bavencio. The recommended dose is 800 mg as an intravenous infusion every 2 weeks. Premedication with acetaminophen and antihistamines is recommended for the first 4 infusions.

As with most checkpoint inhibitors, side effects of avelumab are common and can include fatigue, headache, musculosketetal pain, arthralgia, abdominal pain, diarrhea, nausea, vomiting, decreased appetite, weight loss, fever, cough, dyspnea, pruritus, and rash. Importantly, as a result of the immune enhancement, between 15% and 30% of avelumab treated patients develop immune related side effects, including enterocolitis, dermatitis, endocrinopathy, pneumonitis, neuropathy, nephritis and hepatitis. Most of these reactions respond to discontinuation of avelumab and initiation of immunosuppressive therapy, but some have resulted in fatalities and some have required permanent discontinuation of the checkpoint inhibitor and long term immunosuppressive therapy. Baseline screening and regular monitoring for these adverse events during avelumab therapy is recommended. Early recognition and prompt management of side effects is an integral component of proper use of checkpoint inhibitors. Checkpoint inhibitors should be used only by health care professionals with training in immunotherapy and experience in the management of the side effects of immunomodulatory agents. Other rare but potentially severe adverse effects of avelumab include infusion reactions and embryo-fetal toxicity.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations are not uncommon during avelumab therapy, but are usually self-limited and resolve even with continuing cyclic therapy. These rates of serum enzyme elevations are similar to those with other forms of chemotherapy for advanced malignancies. Serum ALT elevations above 5 times the upper limit of normal (ULN) occur in 1% to 4% of patients and generally lead to temporary discontinuation. Importantly, in 1% to 2% of patients receiving checkpoint inhibitor therapy, the serum enzyme elevations evolve into an immune mediated liver injury that can be clinically apparent and can be severe. The onset of injury is usually after 2 to 4 cycles or 1 to 3 months after starting treatment. The pattern of enzyme elevation is usually hepatocellular but can be mixed or even cholestatic. Liver histology generally demonstrates a pan-lobular hepatitis with focal or confluent necrosis and prominent lymphocytic infiltrates of activated T cells, compatible with an immune mediated hepatic injury. More severe forms of hepatitis may demonstrate centrilobular (zone 3) necrosis. Despite features of immune mediated liver injury, autoantibodies are usually not present and immunoglobulin levels are normal. Because of the serious nature of the liver injury, monitoring with routine liver tests (including alkaline phosphatase) is recommended for patients who receive checkpoint inhibitor therapy. Treatment with corticosteroids generally results in a rapid improvement, allowing for their discontinuation within 1 to 2 months. In some instances, however, the clinical and biochemical response is inadequate, calling for addition of a second immunosuppressive agent such as azathioprine or mycophenolate mofetil. Restarting avelumab or another checkpoint inhibitor after resolution of the hepatic injury is sometimes possible, but can result in recurrence of injury and has not been shown to improve outcome of the cancer chemotherapy.

A proportion of patients receiving avelumab develop cholestatic rather than hepatocellular liver injury. Cholestatic forms of immune mediated liver injury generally arise later than the hepatocellular forms, (after 3 to 10 cycles) and are often accompanied by abdominal pain and jaundice. Alkaline phosphatase levels are markedly elevated while aminotransferase levels are only modestly increased. Imaging studies may show irregular dilatation of the intra- and/or extra-hepatic bile ducts and thickening of the gall bladder and bile duct wall but without evidence of frank obstruction. Liver biopsy shows portal inflammation and bile duct injury and endoscopic biopsy of the bile duct epithelium shows inflammation and scarring. The general features suggest a secondary form of sclerosing cholangitis referred to as checkpoint inhibitor cholangiopathy. Therapy with immunosuppression may improve alkaline phosphatase and bilirubin levels but rarely leads to complete recovery, and long term cholestasis and hepatic failure can occur. Some patients with a cholestatic form of immune related hepatitis do not manifest the large bile duct changes but demonstrate loss and paucity of the smaller, intrahepatic portal bile ducts resulting in a vanishing bile duct syndrome similar to primary biliary cholangitis (PBC).

The effects of PD-L1 inhibition on chronic hepatitis B are not well defined but convincing examples of reactivation of hepatitis B have been described due to other checkpoint inhibitors. Most cases have occurred in patients with preexisting HBsAg, but rare instances were reported in individuals suspected of having with anti-HBc without HBsAg. Thus, screening patients for HBsAg, anti-HBc and anti-HBs is appropriate before initiating immunotherapy with checkpoint inhibitors. Patients with HBsAg should be considered for prophylaxis with an antiviral agent with potent activity against HBV such as entecavir or tenofovir. In patients with anti-HBc without HBsAg, monitoring and close attention to liver test abnormalities is probably adequate if antiviral therapy can be introduced rapidly for early evidence of reactivation. There has not been adequate experience with avelumab in regard to the risk of reactivation of hepatitis B to provide rates of reactivation with and without antiviral prophylaxis.

Likelihood score: B (likely cause of clinically apparent immune mediated liver injury and possible cause of reactivation of hepatitis B).

### Mechanism of Injury

The liver injury due to avelumab is likely immunologically mediated and is usually at least partially responsive to corticosteroid or immunosuppressive therapy. Liver biopsies in cases of hepatocellular injury and bile duct epithelial cell biopsies in cholangiopathic injury demonstrate necrosis and inflammatory cell infiltration with cytotoxic CD8+ T cells, suggesting that the checkpoint inhibition allowed for activation of T cells directed at hepatocyte or cholangiocyte cell surface antigens.

### Outcome and Management

Guidelines for management of patients receiving avelumab recommend monitoring of liver tests and interrupting therapy for patients who develop serum aminotransferase elevations above 3 times the ULN and discontinuing treatment for values above 8 times the ULN in patients without preexisting abnormalities or tumor involvement of the liver (in whom elevations of 5 and 10 times the ULN are used). Corticosteroid therapy can be considered for patients with high or persistent ALT elevations or if symptoms or jaundice arise, initiating therapy with high dose intravenous methylprednisolone and switching to oral prednisone after 1 to 2 days, continuing tapering doses for at least 30 days.

Most cases of hepatitis due to checkpoint inhibitors resolve with prompt institution of immunosuppressive therapy. The few fatal cases that have been reported during immunotherapy with checkpoint inhibitors occurred in patients who had other severe immune related adverse events (Stevens Johnson syndrome, capillary leak syndrome) or who had a cholestatic form of liver injury or delay in receiving corticosteroids. Restarting avelumab after severe liver injury requiring corticosteroid therapy can be followed by recurrence of liver injury and is not recommended. Switching to other checkpoint inhibitors (ipilimumab or anti-PD-1 inhibitors) is more likely to be tolerated. However, survival rates do not seem to be improved by re-introduction of checkpoint inhibitor therapy after severe immune related adverse events. Thus, restarting therapy should be undertaken only after careful evaluation of the residual cancer status.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies, Checkpoint Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Avelumab – Bavencio®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Avelumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Avelumab | 1537032-82-8 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 23 June 2022

Abbreviations used: CPI, checkpoint inhibitor; CTLA-4, cytotoxic T lymphocyte associated antigen 4; HCC, hepatocellular carcinoma; irAE, immune related adverse event; PD-1, programmed cell death receptor 1; PD-L1, programmed cell death receptor ligand-1; NSCLC, non-small cell lung cancer; SCLC, small cell lung cancer.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm?event=overview.process&ApplNo=761049 (FDA website with current and previous product labels and initial 2021 review of the New Drug Application for avelumab; in a pooled analysis of 1738 treated subjects, ALT elevations arose in 21% and were above 5 times ULN in 2.4%, while Alk P elevations occurred in 31% and were above 5 times ULN in 4.2%; serious adverse events included autoimmune hepatitis).
Phan GQ, Yang JC, Sherry RM, Hwu P, Topalian SL, Schwartzentruber DJ, Restifo NP, et al. (2003). Cancer regression and autoimmunity induced by cytotoxic T lymphocyte-associated antigen 4 blockade in patients with metastatic melanoma. Proc Natl Acad Sci U S A. (Initial study of anti-CTLA-4 therapy in 14 patients with melanoma, 6 of whom developed clinically apparent immune adverse reactions, including one with hepatitis arising after the third infusion [ALT 6820 U/L], resolving over the ensuing 4 months with corticosteroid therapy).
Kleiner DE, Berman D. (2012). Pathologic changes in ipilimumab-related hepatitis in patients with metastatic melanoma. Dig Dis Sci. (Clinical and histological features of 5 patients with acute liver injury due to ipilimumab; 3 men and 2 women, ages 43 to 76 years, arising after 2-4 courses, 39-71 days after initial dose [peak bilirubin 1.5-5.1 mg/dL, ALT 326-3070 U/L, Alk P 206-427 U/L], only one had autoantibodies, resolving with immunosuppressive therapy within 1-4 months; one had recurrence on rechallenge; liver biopsies showed acute hepatitis usually with prominent inflammation, interface hepatitis and confluent necrosis: Case 1 Ipilimumab).
Topalian SL, Hodi FS, Brahmer JR, Gettinger SN, Smith DC, McDermott DF, Powderly JD, et al. (2012). Safety, activity, and immune correlates of anti-PD-1 antibody in cancer. N Engl J Med. (Among 296 patients with advanced cancers [melanoma, NSCLC, renal, prostate and colorectal] treated with 1 of 5 doses of nivolumab every 2 weeks, response rates were highest with melanoma and renal cancer, and drug related adverse events were common, including immune related conditions such as pneumonitis [3 fatal], vitiligo, colitis, hepatitis [reversible in all cases], hypophysitis and thyroiditis; ALT elevations occurred in 11 patients [4%] and were greater than 5 times ULN in 2 [1%]).
Brahmer JR, Tykodi SS, Chow LQ, Hwu WJ, Topalian SL, Hwu P, Drake CG, et al. (2012). Safety and activity of anti-PD-L1 antibody in patients with advanced cancer. N Engl J Med. (Among 207 patients with various advanced solid tumors treated with an anti-PD-L1 monoclonal antibody daily for 14 days in 6 week cycles for an average of 12 weeks, durable tumor regression occurred in 6-17% of patients; serious adverse events considered related to therapy occurred in 5%, but no patient had ALT elevations above 5 times ULN).
Teply BA, Lipson EJ. (2014). Identification and management of toxicities from immune checkpoint-blocking drugs. Oncology (Williston Park). (Clinical review of the toxicities of immune checkpoint blocking drugs such as ipilimumab, pembrolizumab and nivolumab; mentions that elevations of serum aminotransferase elevations should lead to careful exclusion of other causes of liver injury and increased monitoring; that elevations above 3 times ULN should lead to withholding the drug and starting corticosteroids; that elevations above 5 times ULN should lead to hospital admission and immediate administration of high doses of corticosteroids).
Tumeh PC, Harview CL, Yearley JH, Shintaku IP, Taylor EJ, Robert L, Chmielowski B, et al. (2014). PD-1 blockade induces responses by inhibiting adaptive immune resistance. Nature. (Analysis of expression of PD-1 and its ligand on CD8+ T cells at the margins of melanoma tumors before and after treatment with pembrolizumab showed that high levels of PD-1 and its ligand are found in responders to therapy).
Sharma P, Allison JP. (2015). The future of immune checkpoint therapy. Science. (Commentary and review of the rationale, history, clinical efficacy and mechanism of action of immune checkpoint therapy).
Abdel-Rahman O, El Halawani H, Fouad M. (2015). Risk of elevated transaminases in cancer patients treated with immune checkpoint inhibitors: a meta-analysis. Expert Opin Drug Saf. (Analysis of publications on checkpoint inhibitors indicate that therapy is associated with higher rates of ALT elevations than with standard of care).
Davar D, Wilson M, Pruckner C, Kirkwood JM. (2015). PD-1 blockade in advanced melanoma in patients with hepatitis C and/or HIV. Case Rep Oncol Med. (59 year old woman and 47 year old man with metastatic melanoma and combined HIV and hepatitis C infection were treated with pembrolizumab, tolerating therapy with no worsening of liver disease or HIV infection).
Kaufman HL, Russell J, Hamid O, Bhatia S, Terheyden P, D'Angelo SP, Shih KC, et al. (2016). Avelumab in patients with chemotherapy-refractory metastatic Merkel cell carcinoma: a multicentre, single-group, open-label, phase 2 trial. Lancet Oncol. (Among 88 patients with chemotherapy refractory Merkel cell carcinoma treated with avelumab [10 mg/kg intravenously every 2 weeks], 28 [32%] developed an objective response including 8 with a complete response, and side effects were common including one patient with ALT elevations above 5 times ULN and one death due to hepatic failure; no details provided).
Apolo AB, Infante JR, Balmanoukian A, Patel MR, Wang D, Kelly K, Mega AE, et al. (2017). Avelumab, an anti-programmed death-ligand 1 antibody, in patients with refractory metastatic urothelial carcinoma: results from a multicenter, phase Ib study. J Clin Oncol. (Among 44 patients with refractory urothelial bladder cancer treated with avelumab, 5 had a complete and 3 a partial response, and adverse reactions included fatigue [32%], infusion reactions [21%], and nausea [11%]; while ALT or AST elevations occurred in 3 patients, only one was above 5 times ULN in whom avelumab was discontinued early).
Heery CR, O'Sullivan-Coyne G, Madan RA, Cordes L, Rajan A, Rauckhorst M, Lamping E, et al. (2017). Avelumab for metastatic or locally advanced previously treated solid tumours (JAVELIN Solid Tumor): a phase 1a, multicohort, dose-escalation trial. Lancet Oncol. (Among 53 patients with various refractory solid tumors treated with 1 of 4 doses of avelumab every 2 weeks, common side effects were fatigue, flu-like symptoms and fever, and 3 developed autoimmune disorders, one with ALT elevations above 5 times ULN).
Gulley JL, Rajan A, Spigel DR, Iannotti N, Chandler J, Wong DJL, Leach J, et al. (2017). Avelumab for patients with previously treated metastatic or recurrent non-small-cell lung cancer (JAVELIN Solid Tumor): dose-expansion cohort of a multicentre, open-label, phase 1b trial. Lancet Oncol. (Among 184 patients with refractory NSCLC treated with avelumab [10 mg/kg every 2 weeks], 22 [12%] had an objective response, but side effects were frequent with immune related events occurring in 22 [12%], although none were liver related).
Kotsakis A, Georgoulias V. (2017). Avelumab, an anti-PD-L1 monoclonal antibody, shows activity in various tumour types. Lancet Oncol. (Commentary on Gulley [2017] and the promise of avelumab in NSCLC).
(2017). In brief: Avelumab (Bavencio) for metastatic merkel cell carcinoma. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of avelumab shortly after its approval in the US as therapy of metastatic Merkel cell carcinoma).
Kim ES. (2017). Avelumab: first global approval. Drugs. (Review of the mechanism of action, pharmacology, clinical efficacy and adverse events of avelumab shortly after its approval for use in Merkel cell carcinoma in the US; mentions that one patient of 88 with Merkel cell cancer developed ALT elevations above 5 times ULN which resolved when avelumab was discontinued, and that there were no deaths that were considered treatment related).
El-Khoueiry AB, Sangro B, Yau T, Crocenzi TS, Kudo M, Hsu C, Kim TY, et al. (2017). Nivolumab in patients with advanced hepatocellular carcinoma (CheckMate 040): an open-label, non-comparative, phase 1/2 dose escalation and expansion trial. Lancet. (Among 262 patients with advanced hepatocellular carcinoma [HCC] treated with nivolumab in dose escalation and expansion studies, objective responses were achieved in 15-20% of patients and toxicity was “manageable”, with ALT elevations in 15% that were above 5 times ULN in 6%; among 51 patients with HBV, all were receiving antiviral prophylaxis and none had HBV reactivation).
Lake AC. (2017). Hepatitis B reactivation in a long-term nonprogressor due to nivolumab therapy. AIDS. (72 year old man with HIV infection, recurrent metastatic lung cancer and anti-HBc without HBsAg was started on dolutegravir and abacavir and then on nivolumab and was found to have acute liver injury 1 month later [bilirubin 0.5 mg/dL, ALT 332 UL, Alk P 205 U/L, HBsAg positive and HBV DNA > 170 million IU/mL], started on tenofovir and later tolerated restarting nivolumab).
Koksal AS, Toka B, Eminler AT, Hacibekiroglu I, Uslan MI, Parlak E. (2017). HBV-related acute hepatitis due to immune checkpoint inhibitors in a patient with malignant melanoma. Ann Oncol. (56 year old man with melanoma and HBsAg in serum developed liver injury 12 weeks after starting ipilimumab [bilirubin 0.7 rising to 1.9 mg/dL, ALT 246 rising to 888 U/L, HBV DNA 244,259 IU/mL], responding to tenofovir and was continued on nivolumab).
Ragunathan K, Dadana S, Huang C-H. (2017). Hepatitis B reactivation after administration of pembrolizumab (Keytruda): a unique case report. Amer J Gastroenterol. (51 year old man with metastatic lung cancer developed liver injury after 1^st^ dose of pembrolizumab and was found to have reactivation of HBV [bilirubin 0.8 mg/dL, ALT 615 U/L, Alk P 64 U/L, HBsAg positive, HBV DNA > 170 million IU/mL], no follow up provided [possibly same patient as in Pandey 2018]).
Karamchandani DM, Chetty R. (2018). Immune checkpoint inhibitor-induced gastrointestinal and hepatic injury: pathologists' perspective. J Clin Pathol. (Review of the pathological findings of immune checkpoint inhibitor associated gastrointestinal and hepatic injury and the role in diagnosis and management of these immune related adverse events).
Cho JH, Sun JM, Lee SH, Ahn JS, Park K, Ahn MJ. (2018). Late-onset cholecystitis with cholangitis after avelumab treatment in non-small cell lung cancer. J Thorac Oncol. (69 year old Japanese woman with adenocarcinoma of the lung had a beneficial response to avelumab given every 2 weeks for 21 cycles, when she developed abdominal pain and had an enlarged thick-walled gallbladder on imaging with mild elevations in ALT and Alk P, responding to high dose corticosteroids but with recurrence of pain and gallbladder abnormalities when avelumab was restarted).
Abu-Sbeih H, Tran CN, Ge PS, Bhutani MS, Alasadi M, Naing A, Jazaeri AA, et al. (2019). Case series of cancer patients who developed cholecystitis related to immune checkpoint inhibitor treatment. J Immunother Cancer. (Among 4253 patients treated with checkpoint inhibitors at the MD Anderson Cancer Center between 2010 and 2018, 25 [0.6%] developed acalculous cholecystitis attributed to the immunotherapy most frequently with anti-CTLA-4 agents alone [1.6%], than anti-PD-1/PD-L1 [0.4%] and combination [0.9%], mean age of patients was 60 years, 60% male, 64% white, median peak ALT 55 U/L, bilirubin 1.4 mg/dL, 20% underwent cholecystectomy, all recovered, 10 [40%] restarted therapy, all without recurrence).
Onoyama T, Takeda Y, Yamashita T, Hamamoto W, Sakamoto Y, Koda H, Kawata S, et al. (2020). Programmed cell death-1 inhibitor-related sclerosing cholangitis: a systematic review. World J Gastroenterol. (Systematic review of reports of sclerosing cholangitis due to check point inhibitors identified 31 cases, ages 43 to 89 years, 68% men, arising after 1 to 27 cycles [median=5.5] with cases due to nivolumab [n=19], pembrolizumab [10], durvalumab [1] and avelumab [1], usually with stenosis or multiple strictures, intra or extrahepatic [or both], median [and range] ALT 125 [31-1536] U/L, Alk P 1543 [237-5060] U/L, poorly responsive to corticosteroids).
Kitagataya T, Suda G, Nagashima K, Katsurada T, Yamamoto K, Kimura M, Maehara O, et al. (2020). Prevalence, clinical course, and predictive factors of immune checkpoint inhibitor monotherapy-associated hepatitis in Japan. J Gastroenterol Hepatol. (Among 202 patients with cancer treated with immune check point inhibitors at a single referral center in Japan, 8 [4%] developed ALT elevations above 5 times ULN [7 women], a median of 42 days after starting therapy, with benign outcomes upon discontinuation, although half required corticosteroid therapy and 2 mycophenolate; 5 of 137 had received nivolumab, 1 of 45 pembrolizumab, 2 of 17 ipilimumab, but none of 3 who had received atezolizumab or avelumab developed immune related hepatitis).
Bang YJ, Ruiz EY, Van Cutsem E, Lee KW, Wyrwicz L, Schenker M, Alsina M, et al. (2018). Phase III, randomised trial of avelumab versus physician's choice of chemotherapy as third-line treatment of patients with advanced gastric or gastro-oesophageal junction cancer: primary analysis of JAVELIN Gastric 300. Ann Oncol. (Among 371 patients with refractory, advanced or metastatic gastric or gastro-esophageal junction carcinoma treated with standard of care or avelumab, overall and progression free survival were similar in the two groups, but adverse events were fewer with avelumab [49% vs 74%] and ALT elevations arose in 3.3% vs 4%, one patient on avelumab developing autoimmune hepatitis requiring discontinuation).
Rajan A, Heery CR, Thomas A, Mammen AL, Perry S, O'Sullivan Coyne G, Guha U, et al. (2019). Efficacy and tolerability of anti-programmed death-ligand 1 (PD-L1) antibody (Avelumab) treatment in advanced thymoma. J Immunother Cancer. (Among 8 patients with thymic tumors treated with avelumab, 4 had an objective response all of whom had immune related adverse events [CPK and ALT elevations], which responded to prednisone suggesting that thymomas may predispose to immune related myositis or hepatitis).
Pu D, Yin L, Zhou Y, Li W, Huang L, Cai L, Zhou Q. (2020). Safety and efficacy of immune checkpoint inhibitors in patients with HBV/HCV infection and advanced-stage cancer: A systematic review. Medicine (Baltimore). (Systematic review of literature on check point inhibitor therapy in patients infected with hepatitis B or C identified 34 articles including 89 patients with HBV and 98 with HCV infection [67% with HCC and 25% with melanoma], among whom reactivation of hepatitis B occurred in two patients and ALT elevations arose in 14% of those with HBV versus 30% with HCV, the elevations rising above 5 times ULN in 3% and 17%).
D'Angelo SP, Bhatia S, Brohl AS, Hamid O, Mehnert JM, Terheyden P, Shih KC, et al. (2020). Avelumab in patients with previously treated metastatic Merkel cell carcinoma: long-term data and biomarker analyses from the single-arm phase 2 JAVELIN Merkel 200 trial. J Immunother Cancer. (Long term outcome of a single arm study of 88 patients with metastatic Merkel cell cancer treated with avelumab found a median overall survival of 12.6 months; with no treatment related deaths, but treatment related adverse events in 77% including ALT elevations in 5% but only one patient had ALT levels above 5 times ULN).
Ruggiero R, Fraenza F, Scavone C, di Mauro G, Piscitelli R, Mascolo A, Ferrajolo C, et al. (2020). Immune checkpoint inhibitors and immune-related adverse drug reactions: data from Italian Pharmacovigilance Database. Front Pharmacol. (Among 2088 safety reports of check point inhibitors enrolled in an Italian pharmacovigilance registry, 801 were immune related including gastrointestinal [33%], skin [17%] and liver [2.7%] due to nivolumab [70%], pembrolizumab [11%], ipilimumab [15%], atezolizumab [4%] and avelumab [<1%]).
Powles T, Park SH, Voog E, Caserta C, Valderrama BP, Gurney H, Kalofonos H, et al. (2020). Avelumab maintenance therapy for advanced or metastatic urothelial carcinoma. N Engl J Med. (Among 700 patients with metastatic urothelial cancer treated with avelumab vs supportive care, the overall 1-year survival was 71% vs 58%, while the adverse event rate was 98% vs 78% and serious adverse events 47% vs 25%; no mention of ALT elevations or hepatotoxicity).
Kelly K, Manitz J, Patel MR, D'Angelo SP, Apolo AB, Rajan A, Kasturi V, et al. (2020). Efficacy and immune-related adverse event associations in avelumab-treated patients. J Immunother Cancer. (Among 1783 patients in two large trials of avelumab in various solid tumors and Merkel cell carcinoma, adverse events arose in all patients which were immune related in 295 [16.5%] and severe in 51 [2.9%] with two deaths from liver injury; 50 and 51 year old women with metastatic breast and gastric cancer who developed acute liver failure after a 3rd and first infusion).
Mizuno K, Ito T, Ishigami M, Ishizu Y, Kuzuya T, Honda T, Kawashima H, et al. (2020). Real world data of liver injury induced by immune checkpoint inhibitors in Japanese patients with advanced malignancies. J Gastroenterol. (Among 546 patients with advanced malignancies treated with checkpoint inhibitors at two Japanese referral centers between 2014 and 2019, high grade, immune mediated liver injury occurred in 29 [5%], mean age 69 years, 73% male, mean onset 52 [range 1-273] days, after 3 [1-15] doses of ipilimumab [6%], nivolumab [54%], pembrolizumab [30%], atezolizumab [6%], durvalumab [2.4%], combination [1.3%], presenting with hepatocellular [21%], cholestatic [59%] or mixed [21%] enzyme elevations, 4 with cholangitis and biliary dilatation without obstruction, only 1 case fatal; predictive factors for injury included ipilimumab [hazard ratio 4.2]).
Lee DW, Cho EJ, Lee JH, Yu SJ, Kim YJ, Yoon JH, Kim TY, et al. (2021). Phase II study of avelumab in patients with advanced hepatocellular carcinoma previously treated with sorafenib. Clin Cancer Res. (Among 30 patients with HCC [26 due to HBV and 3 to HCV] resistant to sorafenib who were then treated with avelumab, there were no complete and only 3 partial responses, and adverse events were frequent including ALT or AST elevations in 37% and bilirubin in 30%, but there were no episodes of reactivation or deaths due to adverse events).
Pujade-Lauraine E, Fujiwara K, Ledermann JA, Oza AM, Kristeleit R, Ray-Coquard IL, Richardson GE, et al. (2021). Avelumab alone or in combination with chemotherapy versus chemotherapy alone in platinum-resistant or platinum-refractory ovarian cancer (JAVELIN Ovarian 200): an open-label, three-arm, randomised, phase 3 study. Lancet Oncol. (Among 566 woman with refractory ovarian carcinoma treated with avelumab or doxorubicin or both, avelumab alone or in combination did not improve either progression-free or overall survival and adverse events were greatest with the combination; ALT elevations arose in 1-2% of patients and one who received avelumab alone developed autoimmune hepatitis).
Park K, Özgüroğlu M, Vansteenkiste J, Spigel D, Yang JCH, Ishii H, Garassino M, et al. (2021). Avelumab versus docetaxel in patients with platinum-treated advanced NSCLC: 2-year follow-up from the JAVELIN lung 200 phase 3 trial. J Thorac Oncol. (Among 792 patients with advanced, refractory NSCLC treated with avelumab or docetaxel, objective response rates were greater with avelumab than docetaxel in subjects with increased PD-L1 expression, and immune related adverse events arose in 17.3% of patients and ALT elevations in 1%).
D'Angelo SP, Bhatia S, Brohl AS, Hamid O, Mehnert JM, Terheyden P, Shih KC, et al. (2021). Avelumab in patients with previously treated metastatic Merkel cell carcinoma (JAVELIN Merkel 200): updated overall survival data after >5 years of follow-up. ESMO Open. (Among 88 patients with Merkel cell carcinoma treated with avelumab followed long term, the overall survival rate was 36% at 2 years and 26% at 5 years while 12% discontinued therapy because of adverse events).
Wong GL, Wong VW, Hui VW, Yip TC, Tse YK, Liang LY, Lui RN, et al. (2021). Hepatitis flare during immunotherapy in patients with current or past hepatitis B virus infection. Am J Gastroenterol. (Among 990 patients in Hong Kong with advanced malignancies treated with checkpoint inhibitors between 2014 and 2019 [397 HBsAg positive, 482 with anti-HBc or anti-HBs, 111 negative for both at baseline], 39% of HBsAg-positive vs 30% of HBsAg-negative patients developed ALT elevations during therapy, but only two cases [both HBsAg positive and on prophylaxis] were due to HBV reactivation).
Mustafayev K, Torres H. Hepatitis B virus and hepatitis C virus reactivation in cancer patients receiving novel anticancer therapies. Clin Microbiol Infect. 2022:S1198-743X(22)00119-7. (Review of the literature on reactivation of HBV and HCV in patients on “novel” anticancer therapy concludes that reactivation can occur with checkpoint inhibitor therapy but largely among HBsAg positive patients and only rarely in patients with resolved hepatitis B).
Yoo S, Lee D, Shim JH, Kim KM, Lim YS, Lee HC, Yoo C, et al. (2022). Risk of hepatitis B virus reactivation in patients treated with immunotherapy for anti-cancer treatment. Clin Gastroenterol Hepatol. (Among 3,465 patients with advanced malignancies treated with checkpoint inhibitors between 2015 and 2020 at a single referral center in Korea, 511 [15%] were HBsAg positive at baseline, reactivation of HBV occurred in 5 of 511 [1%] HBsAg positive vs none of 2,954 HBsAg negative patients, arising in 2 of 464 [0.4%] patients given prophylaxis [both having stopped antivirals] vs 3 of 47 not given prophylaxis [6.4%]; reactivation arising after 3-141 weeks [median 54 weeks] of nivolumab [n=2], pembrolizumab [n=2] or ipilimumab and nivolumab [n=1] treatment, ALT peak 53 to 1768 IU/mL, HBV DNA 6,100 to 3.9 million IU/mL, resolving with 2 to 6 weeks of starting antiviral therapy).

## OTHER REFERENCE LINKS

1 Recent References on Avelumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Avelumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Avelumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Avelumab)